# Onasemnogene Abeparvovec

## OVERVIEW

### Introduction

Onasemnogene abeparvovec is a unique gene therapy agent used to correct the abnormal gene responsible for spinal muscular atrophy type 1, a rare progressive neuromuscular disorder that typically leads to disability and death within the first two years of life. Onasemnogene abeparvovec is given as a one-time intravenous infusion and has been linked to serum aminotransferase elevations which can be associated with jaundice and severe acute liver injury.

### Background

Onasemnogene abeparvovec (on” a sem’ noe jeen a” be par’ voe vek) is a biologic agent and gene therapy designed to correct the gene defect of spinal muscular atrophy (SMA), a rare inherited disease that results in progressive neuromuscular disability leading to severe muscle weakness, paralysis, need for ventilatory support and death usually within the first two years of life. The disease is due to a genetic deficiency in survival motor neuron (SMN) caused by a bi-allelic loss-of-function mutation in the SMN1 gene which is critical for motor neuron survival. The severity of SMA varies based upon the activity and number of copies of the SMN2 gene which ordinarily contributes only a small proportion of needed SMN activity because of the unstable protein variant that it encodes. Despite this limitation, SMN2 expression can partially compensate for the reduction of SMN activity in patients with SMA1, particularly if the SMN2 gene is present in more than 2 copies. Onasemnogene abeparvovec consists of an adeno-associated virus type 9 (AAV9) carrying complementary DNA encoding the missing SMN1 protein. A single infusion leads to widespread and sustained expression of the normal SMN protein in motor neurons as well as other cell types including in heart, muscle, pancreas and liver. In pilot studies a single infusion of onasemnogene abeparvovec led to long term improvements in motor function in infants with SMA1 and survival without ventilatory support beyond the ages predicted by natural history studies of this ordinarily fatal genetic disorder. Onasemnogene abeparvovec was approved for use in the United States in infants with genetically proven SMA1 in 2019. Trials of onasemnogene abeparvovec in other types of SMA and in older subjects are currently ongoing. The recommended dose is 1.1 x 10^14^ vector genomes per kg body weight infused over 60 minutes on a single occasion. Treatment with high doses of systemic corticosteroids starting one day before the infusion and continuing for at least 30 days in gradually reducing doses is recommended. Onasemnogene abeparvovec is available under the commercial name Zolgensma. Adverse events associated with the gene therapy include local injection reactions, nausea, ALT elevations and hypersensitivity reactions. Importantly, serum ALT and AST elevations occur in a high proportion of patients and regular monitoring for the first 3 months after the infusion is required.

### Hepatotoxicity

Prospective studies suggest that 90% of subjects who receive onasemnogene abeparvovec develop some degree of serum aminotransferase elevations during the 1 to 2 months after receipt of the infusion. In a small proportion of infants the elevations are as high as 10 to 20 times the ULN. These abnormalities can be ameliorated, if not prevented, by prophylactic therapy with corticosteroids. Typically, methylprednisolone in doses of 1 mg per kilogram body weight is given the day before the infusion and two days afterward, whereupon it is continued in gradually decreasing doses and with switching to oral prednisolone for a total of 4 weeks. Serum ALT and AST elevations typically arise within the first week after the initial infusion and can reappear during the period of corticosteroid dose reduction. Importantly, in postmarketing studies in more than 300 infants with SMA1, at least two instances of ALT elevations with jaundice and evidence of severe hepatic dysfunction were reported. Reinstitution of high doses of methylprednisolone was followed by clinical recovery and both patients were ultimately able to stop corticosteroids and had evidence of long term improvement in muscle function and development. Onasemnogene abeparvovec should be administered only by physicians with expertise in the management of SMA and in use of this gene therapy and its adverse effects.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of onasemnogene abeparvovec hepatotoxicity is thought to be an immunologic response to the expression of viral vector or SMN gene products by the liver. The liver injury typically arises concurrent with the appearance of anti-AAV9 antibodies. Of interest, cases of severe hepatotoxicity were also observed in early phase clinical trials of a genetic therapy using a related AAV vector (AAV8) in patients with X-linked myotubular myopathy. In addition, liver injury was identified in preclinical studies done in rhesus macaques given an AAV9 vector carrying the human SMN gene. These findings suggest that a number of related AAV vectors may be associated with dose dependent liver injury in susceptible individuals.

### Outcome and Management

Onasemnogene abeparvovec hepatotoxicity is usually responsive to an increase in dose of corticosteroids or their reinstitution if they have been discontinued. Infants receiving this gene therapy should be monitored before and at regular intervals for at least 3 months. Infants with ALT or AST elevations above 10 times ULN after onasemnogene abeparvovec therapy should be treated with reinstitution of high dose corticosteroids and followed carefully during subsequent dose reductions.

Drug Class: Gene Therapy

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Onasemnogene Abeparvovec – Zolgensma®

DRUG CLASS

Gene Therapy

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Onasemnogene)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Onasemnogene Abeparvovec | 1922968-73-7 | Not Applicable | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2020

Abbreviations: AAV, adenovirus associated virus; SMA, spinal muscular atrophy; SMN, survival motor neuron.

Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Kolb SJ, Coffey CS, Yankey JW, Krosschell K, Arnold WD, Rutkove SB, Swoboda KJ, et al. (2017). NeuroNEXT Clinical Trial Network on behalf of the NN101 SMA Biomarker Investigators. Natural history of infantile-onset spinal muscular atrophy. Ann Neurol. (Natural history study of 26 infants with SMA1 demonstrating the rate of motor function deterioration, respiratory failure and survival in untreated infants).
Mendell JR, Al-Zaidy S, Shell R, Arnold WD, Rodino-Klapac LR, Prior TW, Lowes L, et al. (2017). Single-dose gene-replacement therapy for spinal muscular atrophy. N Engl J Med. (Pilot study of onasemnogene abeparvovec given in two dose levels to 15 infants with SMA type 1 found that motor function was preserved and most children were alive and not dependent upon ventilatory support at 2 years of age; three children had ALT and AST elevations following the single infusion of the viral vector with the completatory DNA encoding SMN protein, but all responded to corticosteroid therapy with resolution of the enzyme elevations without long term corticosteroid therapy).
Al-Zaidy SA, Kolb SJ, Lowes L, Alfano LN, Shell R, Church KR, Nagendran S, et al. (2019). AVXS-101 (Onasemnogene Abeparvovec) for SMA1: comparative study with a prospective natural history cohort. J Neuromuscul Dis. (Further follow up of pilot study of onasemnogene abeparvovec [Mendell 2017] and comparison to natural history studies [Kolb 2017] found improved survival [no deaths during 24-33 months of follow up] and improved motor function in infants receiving gene therapy with no new treatment related serious adverse events after the two ALT elevations reported previously).
Hoy SM. (2019). Onasemnogene abeparvovec: first global approval. Drugs. (Review of the development, mechanism of action, in vitro and in vivo effects, clinical efficacy and safety of onasemnogene abeparvovec for infants less than 2 years of age with SMA1 and bi-allelic SMN1 mutations given in a dose of 1.1 x 10^14^ vector genomes/kg in a replication incompetent, self-complementary AAV9 capsid with a copy of the gene encoding the full length human SMN protein under control of the cytomegalovirus enhancer/chicken beta-actin hybrid promoter).
Mahajan R. (2019). Onasemnogene abeparvovec for spinal muscular atrophy: the costlier drug ever. Int J Appl Basic Med Res. (Editorial on the approval of onasemnogene abeparvovec for spinal muscular atrophy makes the point that it is the most costly drug ever).
(2019). Zolgensma - one-time gene therapy for spinal muscular atrophy. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of onasemnogene abeparvovec shortly after its approval in the US as therapy of SMA1 in children below the age of 2, mentions that the infusion can result in significant hepatotoxicity and patients should be given prophylactic corticosteroids).
Stevens D, Claborn MK, Gildon BL, Kessler TL, Walker C. (2020). Onasemnogene abeparvovec-xioi: gene therapy for spinal muscular atrophy. Ann Pharmacother. (Review of the mechanism of action, clinical efficacy and safety of onasemnogene abeparvovec mentions that two treatment related serious adverse events occurred in the initial trial, elevations in serum ALT levels of 14 and 31 times upper limit of normal that resolved with corticosteroid therapy; no further hepatic adverse events being reported in clinical trials and registration studies, although the product has a black box warning about liver injury and prophylactic corticosteroids are recommended).
Waldrop MA, Karingada C, Storey MA, Powers B, Iammarino MA, Miller NF, Alfano LN, et al. (2020). Gene therapy for spinal muscular atrophy: safety and early outcomes. Pediatrics. (Among 21 infants [ages 1 to 23 months] with SMA1 treated with onasemnogene abeparvovec, 89% had improvements in motor function and 11% stabilization, while ALT elevations arose between weeks 1 and 10 in 19 [90%] children and were above 5 times ULN in 6 [29%], highest elevations arising in older infants and those who were noncompliant or intolerant of the recommended corticosteroid doses; all elevations were self-limited, and none were symptomatic or associated with bilirubin elevations).
Feldman AG, Parsons JA, Dutmer CM, Veerapandiyan A, Hafberg E, Maloney N, Mack CL. (2020). Subacute liver failure following gene replacement therapy for spinal muscular atrophy type I. J Pediatr. (Two infants with SMA1, ages 6 and 20 months, who were treated with onasemnogene abeparvovec developed marked serum aminotransferase elevations and jaundice 7 and 8 weeks after the infusion, despite premedication with methylprednisolone and continuation in tapering doses [bilirubin 7.6 and 3.5 mg/dL, ALT 2014 and 1034 U/L, GGT 273 and 572 U/L, Alk P 1074 and 437 U/L, INR 5.3 and 1.5], both responding to reinstitution of high dose intravenous methylprednisone and ultimately resolving without need for long term corticosteroids and with improved motor function suggesting successful gene transfer).

## OTHER REFERENCE LINKS

1 Recent References on Onasemnogene Abeparvovec: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Onasemnogene+AND+Abeparvovec/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Onasemnogene Abeparvovec: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Onasemnogene%20Abeparvovec)